# Tremelimumab

## OVERVIEW

### Introduction

Tremelimumab is a monoclonal antibody check point inhibitor that is used in combination with durvalumab, a second check point inhibitor, in the therapy of unresectable hepatocellular carcinoma (HCC) and non-small cell lung cancer (NSCLC). The combination of tremelimumab and durvalumab is associated with a relatively high rate of serum aminotransferase elevations during therapy and an appreciable rate of clinically apparent immune mediated liver injury which can be severe and even fatal.

### Background

Tremelimumab (tre” me lim’ ue mab) is an IgG2 monoclonal antibody to the cytotoxic T lymphocyte antigen-4 (CTLA-4) which is used in combination with durvalumab, a monoclonal antibody to the programmed cell death receptor ligand-1 (PD-L1), as immune therapy of HCC and NSCLC. Both tremelimumab and durvalumab are check point inhibitors that act by inhibition of cellular pathways that down-regulate immune reactions, thus helping to break tolerance and lead to immune clearance of cancer cells by promoting T cell activation and unleashing cytotoxic antitumor activity. Breaking tolerance, however, can also lead to unintended immune mediated injury to normal tissue. Like other combinations of monoclonal antibody inhibitors of the checkpoint proteins, CTLA-4 and anti-PD-1, tremelimumab combined with durvalumab has enhanced potency but also increased adverse events compared to either agent alone. The combination of tremelimumab with durvalumab has been shown to increase the clinical response rate to chemotherapy in patients with several forms of advanced or metastatic cancer. The combination was given accelerated approval as therapy of unresectable HCC and NSCLC in 2022 and continues to be under evaluation as therapy of other neoplastic diseases. Tremelimumab is available in single use vials of 25 mg in 1.25 mL and 300 mg in 15 mL (both at 20 mg/mL) under the brand name Imjudo. Both agents are administered intravenously and the recommended dose regimen varies by indication and body weight. For adults with body weight more than 30 kg, tremelimumab is recommended in doses of 300 mg and durvalumab in doses of 1500 mg. For HCC, a single priming dose of tremelimumab is given while durvalumab is administered every 4 weeks continuing until disease progression or intolerable toxicity arises. For NSCLC, the combination of tremelimumab 75 mg with durvalumab 1500 mg is given every 3 weeks for 4 cycles, then durvalumab every 4 weeks. Side effects of the combination are common and can include rash, diarrhea, abdominal pain, nausea, vomiting, pruritus, fatigue. More severe adverse events include immune mediated reactions of various organs including pneumonitis, dermatitis, colitis, nephritis, hepatitis and thyroiditis. Because tremelimumab is given in combination with durvalumab, side effects of therapy cannot be reliably attributed to one or the other agent, but durvalumab being given long term is probably responsible for most adverse events. Other severe adverse events with this combination include hypersensitivity reactions, tumor lysis syndrome and embryo-fetal injury.

### Hepatotoxicity

Serum enzyme elevations occur in 41% to 56% of patients taking the combination of tremelimumab and durvalumab and rise to above 5 times the upper limit of normal (ULN) in 8% to 18% of patients. Immune mediated reactions are reported to occur in up to 36% of patients, which are liver related in 7.5% of patients with HCC but less frequently in those with other malignancies. The immune mediated liver injury can be severe, and fatal instances have been reported. Most instances of immune mediated hepatitis ultimately require corticosteroid therapy and result in high discontinuation rates. The immune mediated liver injury typically arises after 1 to 3 infusions and is usually hepatocellular in pattern and may be more related to durvalumab than tremelimumab. Rare instances of cholestatic immune mediated injury have been reported with checkpoint inhibitors, which is typically more severe and protracted and less likely to respond to immunosuppressive therapy. Monitoring of liver tests at the time of monthly infusions is recommended and stopping therapy early may play an important role in preventing severe and fatal outcomes.

The effects of combined CTLA-4 and PD-L1 inhibition on chronic hepatitis B are not well defined but convincing examples of reactivation of hepatitis B have been described due to other checkpoint inhibitors. Most cases have occurred in patients with preexisting HBsAg, but rare instances were reported in individuals suspected of having with anti-HBc without HBsAg. Thus, screening patients for HBsAg, anti-HBc and anti-HBs is appropriate before initiating immunotherapy with checkpoint inhibitors. Patients with HBsAg should be considered for prophylaxis with an antiviral agent with potent activity against HBV such as entecavir or tenofovir. In patients with anti-HBc without HBsAg, monitoring and close attention to liver test abnormalities is probably adequate if antiviral therapy can be introduced rapidly for early evidence of reactivation. There has not been adequate experience with tremelimumab and durvalumab in regard to the risk of reactivation of hepatitis B to provide rates of reactivation with and without antiviral prophylaxis.

Likelihood score: C (probable cause of immune mediated clinically apparent liver injury).

### Mechanism of Injury

The mechanism of tremelimumab immune mediated organ damage is due to inhibition of checkpoint proteins that results in breaking tolerance to self-antigens and T cell activation. Off target T cell activation leads to immune-relayed adverse events such as hepatitis. Liver related immune reactions usually respond to immunosuppressive therapy.

### Outcome and Management

The severity of tremelimumab and durvalumab induced liver injury ranges from transient, asymptomatic elevations in serum enzymes to acute liver injury with jaundice to severe acute liver failure and death. Guidelines for management of patients receiving the combination of tremelimumab and durvalumab recommend monitoring of liver tests and interrupting therapy for patients who develop serum aminotransferase elevations above 3 times the ULN and discontinuing treatment for values above 8 times the ULN in patients without preexisting abnormalities or tumor involvement of the liver (in whom elevations of 5 and 10 times the ULN are used). Corticosteroid therapy can be considered for patients with high or persistent ALT elevations or if symptoms or jaundice arise, initiating therapy with high dose intravenous methylprednisolone and switching to oral prednisone after 1 to 2 days, continuing tapering doses for at least 30 days.

Most cases of hepatitis due to checkpoint inhibitors resolve with prompt institution of immunosuppressive therapy which can be discontinued in 1 to 3 months. In some cases, adding a second agent (such as mycophenolate mofetil, azathioprine, antithymocyte globulin, infliximab or tacrolimus) and prolonged immunosuppression may be necessary. The few fatal cases that have been reported during immunotherapy with checkpoint inhibitors occurred in patients who had other severe immune related adverse events (Stevens Johnson syndrome, capillary leak syndrome) or who had an immune related cholangiopathy or severe acute hepatitis resistant to immunosuppressive therapy. Restarting tremelimumab or durvalumab after severe liver injury requiring corticosteroid therapy can be followed by recurrence of liver injury and is not recommended.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies, Checkpoint Inhibitors

Other Related Drugs: Atezolizumab, Avelumab, Cemiplimab, Cetuximab, Dostarlimab, Durvalumab, Ipilimumab, Nivolumab, Pembrolizumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tremelimumab – Imjudo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tremelimumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tremelimumab | 745013-59-6 (https://pubchem.ncbi.nlm.nih.gov/substance/135304002) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2023

Abbreviations used: CTLA-4, cytotoxic T lymphocyte associated antigen 4; HCC, hepatocellular carcinoma; NSCLC, non-small cell lung cancer; PD-1, programmed cell death receptor 1; PD-L1, programmed cell death receptor ligand-1.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Tremelimumab: Multi-discipline review, 2022. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/761289Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific reviews of the new drug application for safety and efficacy).
Calabrò L, Morra A, Giannarelli D, Amato G, D'Incecco A, Covre A, Lewis A, et al. (2018). Tremelimumab combined with durvalumab in patients with mesothelioma (NIBIT-MESO-1): an open-label, non-randomised, phase 2 study. Lancet Respir Med. (Among 40 patients with unresectable mesothelioma treated with tremelimumab and durvalumab, disease control was achieved in 63% of patients, while adverse events arose in 75% and 3% had ALT elevations, one of which was severe [>20 times ULN] and required early discontinuation and corticosteroid therapy but ultimately resolved).
Schoenfeld JD, Giobbie-Hurder A, Ranasinghe S, Kao KZ, Lako A, Tsuji J, Liu Y, et al. (2022). Durvalumab plus tremelimumab alone or in combination with low-dose or hypofractionated radiotherapy in metastatic non-small-cell lung cancer refractory to previous PD(L)-1 therapy: an open-label, multicentre, randomised, phase 2 trial. Lancet Oncol. (Among 78 patients with refractory metastatic NSCLC treated with tremelimumab and durvalumab with or without radiotherapy, response rates [~11% overall] and adverse events rates [76%] were similar in all groups and ALT elevations above 5 times ULN arose in only one patient).
Somaiah N, Conley AP, Parra ER, Lin H, Amini B, Solis Soto L, Salazar R, et al. (2022). Durvalumab plus tremelimumab in advanced or metastatic soft tissue and bone sarcomas: a single-centre phase 2 trial. Lancet Oncol. (Among 57 patients with advanced or metastatic sarcoma treated with tremelimumab and durvalumab, the clinical response rate was low and adverse events were frequent; but there was no mention of ALT elevations or hepatotoxicity).
Johnson ML, Cho BC, Luft A, Alatorre-Alexander J, Geater SL, Laktionov K, Kim SW, et al., POSEIDON investigators. (2022). Durvalumab with or without tremelimumab in combination with chemotherapy as first-line therapy for metastatic non-small-cell lung cancer: the phase III POSEIDON Study. J Clin Oncol. (Among 1014 patients with metastatic NSCLC treated with tremelimumab and durvalumab with [D+T] or durvalumab alone [D] or with standard chemotherapy alone [CT], overall survival and progression-free survival was greater in the two checkpoint inhibitor arms and all 3 had similar rates of adverse events [93%, 89% and 90%] and deaths from adverse events [3.3%, 2.1% and 2.4%], but rates of immune reactions were greater with D+T [33.6%] than D [19.2%] or CT [5.1%]; ALT elevations arose in 10.3% vs 12.0% and 12.3%, which were above 5 times ULN in 1.2% vs 2.1% vs 2.1%).
Abou-Alfa GK, Lau G, Kudo M, Chan SL, Kelley RK, Furuse J, Sukeepaisarnjaroen W, et al.; HIMALAYA Investigators. Tremelimumab plus durvalumab in unresectable hepatocellular carcinoma. NEJM Evid 2022;1(8). [Not in PubMed] (Among 1171 patients with unresectable hepatocellular carcinoma treated with a single priming dose of tremelimumab with durvalumab every 4 weeks [T+D] vs durvalumab alone [D] vs sorafenib [S], overall survival at 36 months was greatest with T+D [31%], compared to D [25%] and S [20% ], and while overall adverse event rates were similar, severe adverse events were greatest with T+D [40% vs 30% vs 30%] as were any immune reactions [36% vs 17% vs 8%]; any ALT elevation arose in 9% vs 11% vs 5%, ALT elevations above 5 times ULN in 3% vs 3% vs 2%, and liver related immune reactions in 7.5% vs 6.4% vs 0.3%).
Psyrri A, Fayette J, Harrington K, Gillison M, Ahn MJ, Takahashi S, Weiss J, et al. Durvalumab with or without tremelimumab versus the EXTREME regimen as first-line treatment for recurrent or metastatic squamous cell carcinoma of the head and neck: KESTREL, a randomized, open-label, phase III study. Ann Oncol. 2022:S0923-7534(22)04778-0. Epub ahead of print. (Among 823 patients with recurrent or metastatic head and neck cancer treated with tremelimumab with durvalumab [T+D], durvalumab alone [D] or standard of care [SOC], overall survival was similar in the three arms while serious adverse events were more frequent with T+D than D alone [14.5% vs 7.4%]).
Keam SJ. (2023). Tremelimumab: first approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of tremelimumab shortly after its combination with durvalumab was approval for use in unresectable hepatocellular carcinoma [HCC] and metastatic non-small cell lung cancer, mentions that ALT elevations above 5 times ULN arose in 18% and immune related hepatitis in 7.5% of patients receiving the combination of tremelimumab and durvalumab for HCC but less frequently in patients with NSCLC).
de Castro G, Rizvi NA, Schmid P, Syrigos K, Martin C, Yamamoto N, Cheng Y, et al. (2023). NEPTUNE Investigators. NEPTUNE: Phase 3 study of first-line durvalumab plus tremelimumab in patients with metastatic NSCLC. J Thorac Oncol. (Among 823 patients with NSCLC treated with four 4-weekly doses of tremelimumab and long term 4-weekly doses of durvalumab [T+D] vs standard chemotherapy, median overall survival was not different in the two groups [11.7 vs 9.1 months], but adverse event rates were less with T+D [68% vs 82%], and although immune related reactions were more frequent with T+D [33% vs 2%], hepatic related immune reactions were uncommon [2% vs 0%]).

## OTHER REFERENCE LINKS

1 Recent References on Tremelimumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tremelimumab/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tremelimumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tremelimumab)